# Metronidazole

## OVERVIEW

### Introduction

Metronidazole is a nitroimidazole derivative bactericidal agent widely used in the treatment of many anaerobic and certain protozoan and parasitic infections. Metronidazole has been linked to rare instances of acute, clinically apparent liver injury.

### Background

Metronidazole (met" roe nid' a zole) is a nitroimidazole antibiotic that is activated by reduction of its nitro group by susceptible organisms. The activated form of metronidazole is a highly reactive radical anion which targets and damages large protein molecules and DNA. Mammalian cells do not ordinarily activate metronidazole, which accounts for its lack of toxicity in humans. Metronidazole was approved for use in the United States in 1963 and currently several million prescriptions are filled yearly. Metronidazole is indicated for treatment and prophylaxis of infections with susceptible anaerobic bacteria and protozoa. It is used frequently in combination with other antibiotics, proton pump inhibitors and bismuth as therapy of Helicobacter pylori infection. The recommended dosage is 500 to 750 mg taken orally three times daily for 5 to 10 days. Metronidazole is available alone in tablets of 250, 375, 500 and 750 mg as well as in combination with other medications, in multiple generic formulations and under several brand names including Flagyl, Metryl, Noritate, Pylera and Helida. Other formulations include injectable solutions, extended release tablets, suppositories, and topical creams. The most common side effects include metallic taste, nausea, vomiting, abdominal discomfort and diarrhea. Uncommon but potentially severe adverse events include seizures, neuropathy and encephalopathy, hypersensitivity reactions and Stevens-Johnson syndrome. Metronidazole has been found to be carcinogenic in rats and mice and long term and unwarranted use should be avoided.

### Hepatotoxicity

Despite the wide use of metronidazole, only rare cases of hepatotoxicity have been reported, and metronidazole is not listed among causes of drug induced liver injury and acute liver failure in large case series. High doses of metronidazole given parenterally or in an overdose can cause elevations in serum aminotransferase levels, but these are usually self-limited and minimally symptomatic (Case 1). Acute, clinically apparent liver injury from metronidazole is rare. Ornidazole, another synthetic nitroimidazole that was available in Europe, was implicated in several cases of drug induced liver injury, with a latency of a few days or weeks and a hepatocellular pattern of injury. Metronidazole has been associated with a similar acute hepatitis-like syndrome with a short incubation period, but much more rarely. Fever, rash and eosinophilia are uncommon as are autoimmune features. A fatal recurrence of acute liver injury after reexposure to metronidazole has been published (Case 2). Strikingly, multiple instances of metronidazole hepatoxicity have been reported in the rare genetic disease, Cockayne syndrome in which there is an absence or deficiency in an important DNA repair enzyme responsible for nucleotide excision repair. The cases were marked by a short latency (1 to 7 days) to onset of jaundice, a hepatocellular pattern of enzyme elevations and severe course with a high mortality rate. Whether patients with Cockayne syndrome have a similar high risk for severe hepatitis with other nitroimidazoles (such as tinidazole) is not known.

Likelihood score: C (probable rare cause of clinically apparent liver injury).

### Mechanism of Injury

The cause of acute liver injury due to metronidazole is probably immunoallergic, given the short latency period and recurrence with rechallenge. However, the frequency of severe hepatotoxicity in children with Cockayne syndrome suggests a direct toxic effect, probably involving breaks in double stranded DNA. Metronidazole is extensively metabolized in the liver and has multiple drug-drug interactions with agents that induce or inhibit cytochrome P450 enzymes (particularly CYP 3A4).

### Outcome and Management

The liver injury from metronidazole is rare, but can result in liver failure and death. In typical cases, recovery is expected in 1 to 3 months. Rechallenge results in prompt recurrence and should be avoided. Patients with Cockayne syndrome should not receive metronidazole and should best avoid other nitroimidazole antibiotics such as tinidazole.

Drug Class: Antiinfective Agents; Gastrointestinal Agents

Other Drugs in the Subclass, Nitroimidazoles: Benznidazole, Secnidazole, Tinidazole

## CASE REPORTS

### Case 1. Elevations in serum aminotransferase levels during intravenous metronidazole therapy.(1)

A 58 year old man underwent prostate biopsy and cystoscopy and 32 hours later developed fever and was admitted for treatment of suspected urosepsis. After a combination of cephalosporin and tobramycin failed to affect his course, intravenous metronidazole (500 mg every 6 hours) was added. He had rapid clinical improvement, but then complained of abdominal pain, nausea, headache and a metallic taste. Metronidazole was stopped after 5 days and he was switched on oral cefaclor. At the same time, serum ALT and alkaline phosphatase levels were found to be elevated. Physical examination showed slight hepatomegaly without jaundice. Hepatitis B serology was negative. Over the following week, the patient recovered symptomatically and was discharged home. All laboratory tests were normal 4 weeks after stopping metronidazole.

#### Key Points

Medication: | Metronidazole, 500 mg iv every 6 hours for 5 days
Pattern: | Hepatocellular (R=10)
Severity: | 1+ (ALT elevations without jaundice)
Latency: | 5 days
Recovery: | 24 days after stopping
Other medications: | Cefaclor, tobramycin

#### Laboratory Values

Time After Starting | Time After Stopping | ALT (U/L) | Alk P (U/L) | Bilirubin (mg/dL) | Other
Pre | Pre | | 65 | | Prostate biopsy, cystoscopy
| | | | | Fever 104 ^o^F: cefapirin, tobramycin
0 | | Start iv metronidazole | | | Continued fever
5 days | 0 | Stop metronidazole | | | Started cefaclor
6 days | 1 day | 720 | 200 | 0.4 | GGT 459
7 days | 2 days | | 238 | 0.5
9 days | 4 days | 464 | 191 | 0.9
10 days | 5 days | 319
2 weeks | 9 days | 167 | 71 | | Discharged
4 weeks | 24 days | 42 | 80 | 0.3
Normal Values | | <42 | <115 | <1.2

#### Comment

The serum enzyme elevations were compatible with mild metronidazole hepatotoxicity, given the short latency period and rapid recovery after stopping. The rapid onset and rapid recovery after high doses of intravenous metronidazole suggest direct hepatic injury. However, idiosyncratic cases are also marked by short latency period and rechallenge, even with oral metronidazole should be avoided.

### Case 2. Acute hepatocellular injury due to metronidazole with fatal recurrence on reexposure.(2)

A 24 year old woman was treated with metronidazole for Clostridium difficile infection after a course of penicillin for a tooth abscess. Her diarrhea improved, but a few days later she developed nausea and vomiting followed by jaundice. Her past medical history included asthma and frequent upper respiratory infections. Laboratory tests showed total bilirubin of 7.9 mg/dL with marked elevations in serum aminotransferase levels, but modest increase in alkaline phosphatase (Table). Tests for hepatitis A, B and C and for autoantibodies were negative. An ultrasound showed no evidence of biliary obstruction. Metronidazole was discontinued and she began to improve, but her recovery was slow and symptoms persisted for at least two months and laboratory tests did not return to normal for at least nine months. Two years later, she was treated for bacterial vaginitis with metronidazole and tetracycline and one week later developed nausea, vomiting and jaundice. Serum bilirubin was 12.2 mg/dL, ALT and AST were more than 100 fold elevated, and prothrombin index was <9%. She was transferred to a liver transplant center where she developed progressive hepatic coma. Tests for hepatitis A, B and C were again negative. She underwent liver transplantation, but died in the perioperative period. Explant showed massive hepatic necrosis and cholestasis.

#### Key Points

Medication: | Metronidazole (dose and duration not given)
Pattern: | Hepatocellular (R=62)
Severity: | 3+ initially (jaundice and hospitalization) 5+ on reexposure (liver transplantation, death)
Latency: | ~5-10 days
Recovery: | 10 months after initial exposure
Other medications: | Oral tetracycline

#### Laboratory Values

Time After Starting | Time After Stopping | ALT* (U/L) | Alk P (U/L) | Bilirubin (mg/dL) | Other
0 | | Metronidazole given for C difficile
~10 days | 0 | 5282 | 606 | 7.9
15 days | 5 days | 3000 | 500 | 20.1
1 mo | 1 mo | 104 | 450 | 10.5
2.5 mos | 2.5 mos | 102 | 492 | 1.0
9 mos | 9 mos | 84 | <300 | 1.0
| 26 mos | Metronidazole given for bacterial vaginitis
~7 days | 0 | 11104 | 810 | 12.2 | Protime index < 9%
~10 days | ~3 days | | | 20.5 | Liver transplant, post-operative death
Normal Values | | <42 | <300 | <1.2

* Values estimated from Figure 1. Bilirubin results converted from mol to mg/dL (17.1) and enzyme results converted from kat to U/L (0.01667).

#### Comment

Severe acute hepatocellular injury from a short course of metronidazole with slow recovery, followed by a rapid and fatal recurrence on reexposure.

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Metronidazole – Generic, Flagyl®

DRUG CLASS

Antiinfective Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=metronidazole)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NO | MOLECULAR FORMULA | STRUCTURE
Metronidazole | 443-48-1 | C6-H9-N3-O3

## CITED REFERENCES

1 Appleby DH, Vogtland HD. (1983). Suspected metronidazole hepatotoxicity. Clin Pharm.
2 Björnsson E, Nordlinder H, Olsson R. (2002). Metronidazol as a probable cause of severe liver injury. Hepatogastroenterology.

## ANNOTATED BIBLIOGRAPHY

References updated: 20 February 2020

Zimmerman HJ. Amebicides. Hepatic injury from antimicrobial agents. In, Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999, p. 592. (Expert review of liver injury published in 1999 mentions that metronidazole has only rarely been incriminated in causing liver injury).
Moseley RH. Hepatotoxicity of antimicrobials and antifungal agents. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013, pp. 463-82. (Review of hepatotoxicity of antibiotics; does not discuss metronidazole).
Wetzel DM, Phillips MA. Chemotherapy of protozoal infections. In, Brunton LL, Hilal-Dandan R, Knollman BC, eds. Goodman & Gilman’s the pharmacological basis of therapeutics. 13th ed. New York: McGraw-Hill, 20181, pp. 987-1000. (Textbook of pharmacology and therapeutics).
Fagin ID. (1965). Jaundice associated with metronidazole. Letter to editor. JAMA. (46 year old man developed fever after 4 days of metronidazole [250 mg/day] and he was given an injection of penicillin; 6 days later, he developed jaundice [bilirubin 5.4 mg/dL, AST 143 U/L, Alk P 1.5 times ULN], resolving in 2 months).
Bonfiglio G, Donadio G. (1967). Results of the clinical testing of a new drug metronidazole in the treatment of chronic alcoholism. Br J Addict. (Open label trial of metronidazole [750 mg daily] in 60 patients with alcoholism for up to 45 days, most patients had flushing response to alcohol; no mention of hepatotoxicity or ALT elevations).
(1983). Prospective, randomized comparison of metronidazole and clindamycin, each with gentamicin, for the treatment of serious intra-abdominal infection. Surgery. (Multicenter study comparing clindamycin to metronidazole in 186 patients with severe infections; similar efficacy, AST elevations in 18% on metronidazole vs 10% on clindamycin, but no frank hepatitis or discontinuation for liver injury).
Appleby DH, Vogtland HD. (1983). Suspected metronidazole hepatotoxicity. Clin Pharm. (58 year old man with urosepsis developed ALT [735 U/L] and Alk P [238 U/L] elevations without jaundice after 4 days of iv metronidazole, resolving in 1 week; also received tobramycin and cefapirin: Case 1).
Uchihara M, Maeda M, Koyama W, Sakamoto S, Kanayama M. (1984). A case of metronidazole-induced liver injury. Acta Hepatol Jpn. (35 year old man developed fever, abdominal discomfort, eosinophilia and enzymes elevations [bilirubin 1.6 mg/dL, ALT 478 U/L, Alk P 469 U/L] after 2 weeks of oral metronidazole, with positive lymphocyte stimulation test, recovery in 4 weeks).
Smilack JD, Wilson WR, Cockerill FR. (1991). Tetracyclines, chloramphenicol, erythromycin, clindamycin, and metronidazole. Mayo Clin Proc. (Review of uses and toxicities of antibiotics; no mention of hepatotoxicity of metronidazole).
Hestin D, Hanesse B, Frimat L, Trechot P, Netter P, Kessler M. (1994). Metronidazole-associated hepatotoxicity in a hemodialyzed patient. Nephron. (68 year old woman developed nausea and right upper quadrant pain after 1 week of oral metronidazole therapy; ALT 650 U/L but no jaundice, resolved within 15 days of stopping).
Lam S, Bank S. (1995). Hepatotoxicity caused by metronidazole overdose. Ann Intern Med. (58 year old woman took an overdose of metronidazole ~12.5 g and developed asymptomatic rise in ALT [to 2570 U/L], AST [6120 U/L], but minimal increase in Alk P [95 U/L] and bilirubin [2.1 mg/dL], levels peaking 2-3 days after overdose and resolving to normal within 4 weeks).
Koşar Y, Sasmaz N, Oguz P, Kacar S, Erden E, Parlak E, Akdogan M. (2001). Ornidazole-induced autoimmune hepatitis. Eur J Gastroenterol Hepatol. (35 year old woman developed jaundice within a few days of starting oral ornidazole [bilirubin 17 mg/dL, ALT 1140 U/L, Alk P 145 U/L, SMA 1:1280], responding to corticosteroids with no relapse when therapy was stopped, but she was then retreated with ornidazole and promptly redeveloped a similar clinical picture with rise in SMA from 1:80 to 1:1280).
Björnsson E, Nordlinder H, Olsson R. (2002). Metronidazol as a probable cause of severe liver injury. Hepatogastroenterology. (24 year old woman treated with metronidazole for pseudomembranous colitis developed symptoms and jaundice a few days later with progression to acute hepatitis [bilirubin 7.9 mg/dL, ALT 100 times ULN, Alk P 2 times ULN], with slow and incomplete recovery, and relapse and acute liver failure with retreatment with metronidazole 2 years later, the explant showing massive necrosis: Case 2).
Tabak F, Ozaras R, Erzin Y, Celik AF, Ozbay G, Senturk H. (2003). Ornidazole-induced liver damage: report of three cases and review of the literature. Liver Int. (Ornidazole, a nitroimidazole derivative similar to metronidazole, was linked to 3 cases of acute hepatitis in women ages 25-50 years, arising after 3-4 days of therapy with ALT 977, 3042 and 1160 U/L; Alk P 1062, 422 and 431 U/L; bilirubin 32, 48 and 10 mg/dL, resolving in 1-2 months, no autoantibodies or allergic findings; 6 cases in literature, 4 icteric, 1 fatal).
Orion E, Matz H, Wolf R. (2005). The life-threatening complications of dermatologic therapies. Clin Dermatol. (Review of serious complications of medications of skin disorders, mentions hepatotoxicity of metronidazole briefly).
Chalasani N, Fontana RJ, Bonkovsky HL, Watkins PB, Davern T, Serrano J, Yang H, Rochon J, Drug Induced Liver Injury Network (DILIN). (2008). Causes, clinical features, and outcomes from a prospective study of drug-induced liver injury in the United States. Gastroenterology. (Among 300 cases of drug induced liver disease in the US collected from 2004 to 2008, no case was attributed to metronidazole).
Hussein R, El-Halabi M, Ghaith O, Jurdi N, Azar C, Mansour N, Sharara AI. (2011). Severe hepatotoxicity associated with the combination of spiramycin plus metronidazole. Arab J Gastroenterol. (Three men, ages 22 to 41 years, developed jaundice “a few weeks” to 2 months after treatment with a fixed combination of spiramycin and metronidazole [Rodogyl] for dental infections [bilirubin 28, 8.0 and 11.3 rising to 24 mg/dL, ALT 210, 1900 and 188 U/L, Alk P 109 and 344 U/L], one recovering spontaneously, one treated with prednisone and one undergoing emergency liver transplantation).
Abdel Ghaffar TY, Elsobky ES, Elsayed SM. (2011). Cholestasis in patients with Cockayne syndrome and suggested modified criteria for clinical diagnosis. Orphanet J Rare Dis. (Among 9 patients with Cockayne syndrome followed at a single Egyptian referral center, 7 had at least one episode of transient liver injury, 4 with jaundice and 2 resulting in death, often following bacterial infections, an anesthetic agent being implicated in one instance).
Kancherla D, Gajendran M, Vallabhaneni P, Vipperla K. (2013). Metronidazole induced liver injury: a rare immune mediated drug reaction. Case Rep Gastrointest Med. (54 year old man developed jaundice a few weeks after a 2 week course of metronidazole for Clostridium difficile associated diarrhea [bilirubin 7.2 mg/dL, ALT 973 U/L, Alk P 96 U/L, INR 1.9], with a severe and prolonged course, corticosteroid therapy, but eventual recovery).
Björnsson ES, Bergmann OM, Björnsson HK, Kvaran RB, Olafsson S. (2013). Incidence, presentation and outcomes in patients with drug-induced liver injury in the general population of Iceland. Gastroenterology. (In a population based study of drug induced liver injury from Iceland, 96 cases were identified over a 2 year period, but none of the 96 were attributed to metronidazole).
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al.; United States Drug Induced Liver Injury Network. Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology 2015; 148: 1340-52e7. (Among 899 cases of drug induced liver injury enrolled in a US prospective study between 2004 and 2013, none were attributed to metronidazole).
Wilson BT, Strong A, O'Kelly S, Munkley J, Stark Z. (2015). Metronidazole toxicity in Cockayne syndrome: a case series. Pediatrics. (Case series of 4 patients [ages 1-21 years; 3 girls, 1 boy] with Cockayne syndrome who developed jaundice and severe liver injury within 1-7 days of starting metronidazole usually in high doses [initial bilirubin 1.9-7.5 mg/dL, ALT 544-6206 U/L, Alk P 273-848 U/L, INR 1.4->10], 3 dying and 1 surviving after a prolonged course).
Blumenthal KG, Youngster I, Rabideau DJ, Parker RA, Manning KS, Walensky RP, Nelson SB. Peripheral blood eosinophilia and hypersensitivity reactions among patients receiving outpatient parenteral antibiotics. J Allergy Clin Immunol 2015; 136: 1288-94. e1. (Among 824 patients receiving outpatient parenteral antibiotic therapy who had concurrent white blood cell and differential counts, eosinophilia [>500 cells/uL] was found in 25%, being most common with vancomycin [30%], the penicillins [28%], carbapenems [28%], cephalosporins [22%], fluoroquinolones [21%], and less common with metronidazole [15%] and there was no association of eosinophilia with liver test abnormalities).
Mazuski JE, Gasink LB, Armstrong J, Broadhurst H, Stone GG, Rank D, Llorens L, et al. (2016). Efficacy and safety of ceftazidime-avibactam plus metronidazole versus meropenem in the treatment of complicated intra-abdominal infection: results from a randomized, controlled, double-blind, phase 3 program. Clin Infect Dis. (In a randomized trial of ceftazidime/avibactam and metronidazole vs meropenem only for complicated intra-abdominal infections, cure rates were similar for the two regimens [82% vs 85%] as were adverse events including “liver disorders” of 2.1% vs 1.5%).
(2017). Drugs for Helicobacter pylori infection. Med Lett Drugs Ther. (Concise review of the efficacy, safety and costs of drugs for H. pylori infection lists preferred regimens, usually includes metronidazole [500 mg twice daily for 10-14 days] whose adverse effects can include metallic taste, reactions to alcohol, seizures and neuropathy).
Zhao Z, Bao L, Yu X, Zhu C, Xu J, Wang Y, Yin M, et al. (2017). Acute vanishing bile duct syndrome after therapy with cephalosporin, metronidazole, and clotrimazole: A case report. Medicine (Baltimore). (29 year old woman developed progressive, severe cholestasis and bile duct loss attributed to a 4-5 day course of antibiotics, reportedly “a cephalosporin”, metronidazole and clotrimazole).
Pandey S, Gupta GK, Wanjari SJ, Nijhawan S. (2018). Comparative study of tinidazole versus metronidazole in treatment of amebic liver abscess: A randomized control trial. Indian J Gastroenterol. (Among 150 patients with amebic liver abscess treated with metronidazole [14 days] or tinidazole [5 days], time to response was better with tinidazole but ultimate response rates were similar, although metronidazole was associated with a higher rate of adverse events including nausea, vomiting and metallic taste resulting in early discontinuation in 10%; no mention of ALT elevations or hepatotoxicity).
Shamberg L, Vaziri H. (2018). Hepatotoxicity of inflammatory bowel disease medications. J Clin Gastroenterol. (Review of the hepatotoxicity of drugs used for inflammatory bowel disease mentions that metronidazole has been reported to cause liver injury but it is rare and does not justify prospective monitoring during therapy).
Ataee P, Karimi A, Eftekhari K. (2020). Hepatic failure following metronidazole in children with Cockayne syndrome. Case Rep Pediatr. (Two cases: 2 and 5 years old boys with type B [infant onset] Cockayne syndrome developed jaundice, vomiting and agitation 2 and 3 days after starting oral metronidazole for minor infection [bilirubin 13.7 and 16.0 mg/dL, ALT 2815 and 2248 U/L, Alk P 1265 and 1654 U/L, INR 5.1 and 4.6], one dying within 2 days of admission and the second recovering but with persistent jaundice and serum enzyme elevations one month later).

## OTHER REFERENCE LINKS

1 Recent References on Metronidazole: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=metronidazole/AE+AND+Human%5BMH%5D+AND+(%20drug-induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%222009/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))
2 Trials on Metronidazole: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=metronidazole)